# Belinostat

## OVERVIEW

### Introduction

Belinostat is an intravenously administered histone deacetylase inhibitor and antineoplastic agent that is approved for use in refractory or relapsed peripheral T cell lymphoma. Belinostat is associated with moderate rate of minor serum enzyme elevations during therapy and has been reported to cause clinically apparent fatal, acute liver injury.

### Background

Belinostat (be lin' oh stat) is a parenterally administered small molecule inhibitor of histone deacetylase which acts by preventing removal of acetyl groups from histones. Accumulation of acetyl groups on histones causes cell cycle arrest and apoptotic cell death. Malignant cells and particularly malignant T cells are particularly sensitive to the effects of inhibition of histone deacetylases. In open label studies in patients with refractory or relapsed peripheral T cell lymphoma (PTCL), monotherapy with belinostat yielded an overall response rate of 26% and some responders had long term remissions and were able to undergo hematopoietic cell transplantation. Belinostat was approved for use in the United States in 2014 as monotherapy for refractory or relapsing peripheral T cell lymphoma. Belinostat is available as a lyophilized powder for reconstitution in 500 mg single use vials under the commercial name Beleodaq. The recommended dose is 1 gm/m^2^ given intravenously on days 1 to 5 in 21 day cycles, which are repeated until there is disease progression or unacceptable toxicity. Side effects are common, but usually mild-to-moderate in severity, and include nausea, fatigue, fever, anemia, neutropenia, thrombocytopenia, constipation, rash, edema, cough and pruritus. Side effects lead to early discontinuation in up to 20% of patients. Severe adverse events can include marked neutropenia, thrombocytopenia, serious infections, sepsis, tumor lysis syndrome and acute liver failure.

### Hepatotoxicity

In clinical trials of belinostat in patients with PTCL, the rates of serum enzyme elevations during therapy were usually less than 5%, and were above 5 times the ULN in only 1% to 2% of patients. A single instance of severe acute liver injury leading to death from liver failure was reported in an open label trial of belinostat monotherapy in 120 patients with PTCL. The liver injury arose after 10 cycles of treatment and progressed despite drug discontinuation. Specific details were not provided. In another clinical trial, two cases of cholestatic liver injury were reported but without specific details. Thus, belinostat is considered to be a rare cause of acute liver injury but the timing of onset, associated features, clinical course and outcome have not been well defined.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why belinostat causes serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of histone deacetylase or other enzyme activities. Belinostat is metabolized in the liver by UGT1A1 and the cytochrome P450 isozymes CYP 2A6, 2C9 and 3A4, so that it may cause drug-drug interactions, and hepatotoxicity could be the result of production of a toxic or immunogenic intermediate. Finally, belinostat is a sulfonamide hydroxyamide and severe acute liver injury from belinostat might be the result of a sulfonamide-like hepatic reaction.

### Outcome and Management

Serum enzyme elevations are uncommon during belinostat therapy and are rarely dose limiting. Belinostat should not be used with other agents with hepatotoxic potential. Furthermore, regular monitoring of liver tests with each course of therapy is recommended, with more frequent monitoring if serum aminotransferase values rise. Belinostat should be held if ALT or AST values rise above 5 times the ULN. Elevations of more than 20 times the ULN or appearance of jaundice or symptoms of liver injury should trigger permanent discontinuation. There is no known cross sensitivity to hepatic injury among the different histone deacetylase inhibitors. Because belinostat is a sulfonamide derivative, it should be used with caution in patients with a history of sulfa allergy.

Drug Class: Antineoplastic Agents, Histone Deacetylase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Belinostat – Beleodaq®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=belinostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Belinostat | 866323-14-0 | C15-H14-N2-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Abbreviation: PTCL, peripheral T-cell lymphoma.
Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of histone deacetylase inhibitors).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss belinostat).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1230. (Textbook of pharmacology and therapeutics).
Mackay HJ, Hirte H, Colgan T, Covens A, MacAlpine K, Grenci P, Wang L, et al. (2010). Phase II trial of the histone deacetylase inhibitor belinostat in women with platinum resistant epithelial ovarian cancer and micropapillary (LMP) ovarian tumours. Eur J Cancer. (Among 32 women with refractory ovarian carcinoma treated with belinostat, the overall response rate was 3% and common side effects included fatigue [69%], nausea [59%], diarrhea [28%], neuropathy [16%] and Alk P elevations [6%], but there were no cases of clinically apparent liver injury).
Dizon DS, Blessing JA, Penson RT, Drake RD, Walker JL, Johnston CM, Disilvestro PA, et al. (2012). A phase II evaluation of belinostat and carboplatin in the treatment of recurrent or persistent platinum-resistant ovarian, fallopian tube, or primary peritoneal carcinoma: a Gynecologic Oncology Group study. Gynecol Oncol. (Among 27 women with refractory ovarian carcinoma treated with belinostat and carboplatin, the overall response rate was 7% and severe side effects included neutropenia [22%], thrombocytopenia [15%] and vomiting [11%]; no mention of ALT elevations or hepatotoxicity).
Cashen A, Juckett M, Jumonville A, Litzow M, Flynn PJ, Eckardt J, LaPlant B, et al. (2012). Phase II study of the histone deacetylase inhibitor belinostat (PXD101) for the treatment of myelodysplastic syndrome (MDS). Ann Hematol. (Among 21 patients with refractory myelodysplastic syndromes treated with belinostat, the overall response rate was 5% and 90% had severe cytopenias, 2 had cytokine release syndrome and 2 had QTc prolongations; no mention of ALT elevations or hepatotoxicity).
Reimer P, Chawla S. (2013). Long-term complete remission with belinostat in a patient with chemotherapy refractory peripheral T-cell lymphoma. J Hematol Oncol. (73 year old woman with refractory PTCL had a complete response after 2 cycles of belinostat, which was then continued for 2 years with maintained response thereafter; side effects included cytopenias, 3 bouts of C. difficile colitis and 1 episode of pneumonia).
Kirschbaum MH, Foon KA, Frankel P, Ruel C, Pulone B, Tuscano JM, Newman EM. (2014). A phase 2 study of belinostat (PXD101) in patients with relapsed or refractory acute myeloid leukemia or patients over the age of 60 with newly diagnosed acute myeloid leukemia: a California Cancer Consortium Study. Leuk Lymphoma. (Among 12 patients with AML treated with belinostat, none had even a partial response and side effects included ALT elevations in 4 patients [33%], although all were transient and less than 5 times ULN).
Foss F, Advani R, Duvic M, Hymes KB, Intragumtornchai T, Lekhakula A, Shpilberg O, et al. (2015). A Phase II trial of Belinostat (PXD101) in patients with relapsed or refractory peripheral or cutaneous T-cell lymphoma. Br J Haematol. (Among 24 patients with refractory PTCL and 29 with cutaneous TCL treated with belinostat, overall response rates were 25% and 14% and adverse events occurred in 77%, including 2 patients with ALT or AST elevations above 5 times ULN, one of whom stopped therapy for this reason).
O'Connor OA, Horwitz S, Masszi T, Van Hoof A, Brown P, Doorduijn J, Hess G, et al. (2015). Belinostat in patients with relapsed or refractory peripheral T-cell lymphoma: results of the pivotal phase II BELIEF (CLN-19) study. J Clin Oncol. (Among 120 patients with refractory PTCL treated with belinostat for up to 2 years, the overall response rate was 26%, and side effects were common [97%] and included two cases of ALT elevations above 5 times ULN and one that led to hepatic failure shortly after starting cycle 10).
(2015). Belinostat (Beleodaq) for peripheral T-Cell lymphoma. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy, safety and cost of belinostat shortly after its approval for use in PTCL in the US, mentions that reported serious adverse events include fatal hepatotoxicity).
Lee HZ, Kwitkowski VE, Del Valle PL, Ricci MS, Saber H, Habtemariam BA, Bullock J, et al. (2015). FDA approval: belinostat for the treatment of patients with relapsed or refractory peripheral T-cell lymphoma. Clin Cancer Res. (Summary of evidence that supported the accelerated approval of belinostat for PTCL, largely from the open label trial reported by O’Connor [2015] demonstrating a 26% overall response rate and acceptable toxicity; 4 patients [3%] developed tumor lysis syndrome and there were 9 deaths during the trial including one from hepatic failure that was the only one judged to be related to therapy).
Lunning MA. (2015). Treatment of peripheral T-cell lymphoma: many shades of gray. Oncology (Williston Park). (Review of PTCL which represents 10% of cases of non-Hodgkin lymphoma and is often refractory to conventional cytotoxic therapies; recently 4 new agents have been approved for use in PTCL including pralatrexate [2009], romidepsin [2011], brentuximab vedotin [2011] and belinostat [2014]).
Puvvada SD, Li H, Rimsza LM, Bernstein SH, Fisher RI, LeBlanc M, Schmelz M, Glinsmann-Gibson B, et al. (2016). A phase II study of belinostat (PXD101) in relapsed and refractory aggressive B-cell lymphomas: SWOG S0520. Leuk Lymphoma. (Among 22 patients with refractory or relapsing B cell lymphoma treated with belinostat for up to two years, the overall response rate was only 10% and side effects were common, although usually tolerated; no mention of ALT elevations or hepatotoxicity).
Moskowitz AJ, Horwitz SM. (2017). Targeting histone deacetylases in T-cell lymphoma. Leuk Lymphoma. (Extensive review of the mechanism of action, classification, clinical efficacy and safety of histone deacetylase inhibitors in T-cell lymphomas, mentions that belinostat is a parenterally administered hydroxamate that is approved for use in refractory or relapsed peripheral T cell lymphoma, more common adverse effects of which are nausea, vomiting, fatigue, diarrhea, constipation, fever and dizziness;, no mention of ALT elevations or hepatotoxicity).
Shah RR. (2019). Safety and tolerability of histone deacetylase (HDAC) inhibitors in oncology. Drug Saf. (Review of the safety of histone deacetylase inhibitors approved for use in the US mentions that elevations in serum aminotransferase levels have been reported during therapy with romidepsin, panobinostat and belinostat but not with vorinostat, and there have been no reports of clinically apparent hepatotoxicity, except for a single case of hepatic failure arising during a clinical trial of belinostat [O’Connor 2015]).

## OTHER REFERENCE LINKS

1 Recent References on Belinostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=belinostat/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Belinostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=belinostat)